# Fedratinib

## OVERVIEW

### Introduction

Fedratinib is an oral selective inhibitor of Janus associated kinase 2 (JAK-2) and FMS-like tyrosine kinase 3 (FLT3) that is used in the therapy of intermediate or high-risk, primary or secondary myelofibrosis. Fedratinib has been associated with a high rate of serum enzyme elevations during therapy, but has been associated with only rare instances of clinically apparent acute liver injury.

### Background

Fedratinib (fed ra’ ti nib) is an orally available, small molecule inhibitor of Janus associated kinase-2 (JAK-2) and the FMS-like tyrosine kinase 3 (FLT-3), which are often mutated in patients with primary and secondary myelofibrosis. Myelofibrosis is a myeloproliferative, neoplastic syndrome that can present de novo (primary) or after transformation of polycythemia vera or essential thrombocytopenia (secondary). Clinical features include splenomegaly and debilitating constitutional symptoms of fatigue, fever, weight loss, bone pain, pruritus and failure to thrive. The bone marrow exhibits progressive replacement of marrow by fibrosis with associated anemia and thrombocytopenia. The marrow also frequently harbors mutated forms of JAK-2 [V617F] that are associated with dysregulation of the signal transducer and activator of transcription (STAT) pathway, resulting in abnormal cell proliferation and unregulated production of growth factors and pro-inflammatory cytokines. Myelofibrosis is a pre-malignant syndrome that eventually transforms into leukemia in up to 20% of cases. Therapy for myelofibrosis is unsatisfactory. The JAK-1/2 inhibitor ruxolitinib is approved for use in myelofibrosis, but the response rate is less than 50%, and it is often poorly tolerated. The finding of frequent mutations in JAK-2 and FLT-3 in the bone marrow of patients with primary or secondary myelofibrosis led to the clinical evaluation of fedratinib. In several preregistration trials, fedratinib resulted in reduction of splenomegaly and improvement in symptoms in 40% to 50% of patients, including those who were resistant to or intolerant of ruxolitinib. Fedratinib was approved in the United States as therapy for intermediate- or high-risk primary or secondary myelofibrosis in 2019. Fedratinib is available in capsules of 100 mg under the brand name Inrebic. The recommended dose is 400 mg once daily with dose reductions for adverse events. Common side effects include mild-to-moderate symptoms of diarrhea, nausea and vomiting, anemia, thrombocytopenia, fatigue, headache, pruritus, muscle spasms, and elevations in serum creatinine, lipase, amylase and aminotransferase levels. Uncommon, but potentially serious side effects include severe anemia and thrombocytopenia, renal, pancreatic and liver toxicity, Wernicke’s encephalopathy, secondary malignancies, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure clinical trials of fedratinib in patients with myelofibrosis, liver test abnormalities were common but also found in a proportion of patients treated with placebo or with a comparator drug. Some degree of ALT elevation arose in up to 58% of fedratinib treated patients, compared to 14% to 17% of those treated with placebo, but were above 5 times the upper limit of normal (ULN) in 9% or less and were usually not accompanied by symptoms or jaundice. Nevertheless, at least one case of severe acute hepatitis with hepatic failure was reported in an early study of fedratinib. Subsequently, with more careful monitoring, instances of clinically apparent liver injury were not reported. Clinical experience with fedratinib since its approval has been limited.

In addition, long term treatment with fedratinib and other Janus kinase inhibitors has been linked to rare instances of reactivation of hepatitis B that can be severe and even fatal. Reactivation often becomes clinically apparent after the JAK inhibitor is discontinued, when immune restoration results in an immunologic response to the heightened viral replication.

Likelihood score: D (possible rare cause of clinically apparent liver injury including reactivation of hepatitis B in susceptible patients).

### Mechanism of Injury

The cause of liver injury from fedratinib is unknown, but the pattern of abnormalities suggests some degree of low level, direct hepatotoxicity. Thus, minor ALT elevations levels occur in over 40% of treated patients, but they are usually asymptomatic and transient, resolving even without dose modification or interruption. Fedratinib is metabolized in the liver via the cytochrome P450 system, largely CYP 3A4, and is susceptible to drug-drug interactions with agents that inhibit or induce the CYP enzyme reactivity.

Reactivation of hepatitis B by JAK inhibitors, in contrast, is likely due to indirect effects caused by immune suppression, which may to lead to increased HBV replication and which, if followed by immune recovery, can result in acute liver injury.

### Outcome and Management

Patients receiving fedratinib should be tested before starting therapy for thiamine levels, complete blood count, creatinine, blood urea nitrogen, routine liver tests and amylase and lipase levels. These tests should then be monitored as clinically indicated during therapy. Serum aminotransferase elevations typically arise within 1 to 3 months of starting fedratinib and are mild. Levels above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary interruption. In patients who develop clinical symptoms or jaundice with these elevations, fedratinib should be promptly discontinued, and restarting therapy should be done with caution and close monitoring. Cross sensitivity to liver injury is uncommon among the tyrosine kinase inhibitors but there is no information on shared adverse event sensitivity between other JAK inhibitors (such as ruxolitinib) and fedratinib.

Other JAK inhibitors such as baricitinib, tofacitinib, ruxolitinib, and upadacitinib have been linked to cases of reactivation of hepatitis B which can be severe. Importantly, patients who are to receive long term therapy with fedratinib should be screened for hepatitis B (HBsAg and anti-HBc). Patients with HBsAg in serum should be treated prophylactically with an oral antiviral agent with activity against HBV such as entecavir or tenofovir. An alternative, which is applicable to those with anti-HBc without HBsAg, is to monitor patients carefully for HBV DNA levels to detect evidence of reactivation early and initiate appropriate therapy for HBV infection.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Drugs in the Subclass, Janus Kinase Inhibitors: Baricitinib, Ruxolitinib, Tofacitinib, Upadacitinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fedratinib – Inrebic®

DRUG CLASS

Antineoplastic Agents, Tyrosine Kinase Inhibitor

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fedratinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Fedratinib | 936091-26-8 | C27-H36-N6-O3-S

## ANNOTATED BIBLIOGRAPHY

References updated: 20 August 2022

Abbreviations: FLT-3, FMS-like tyrosine kinase; HBV, hepatitis B virus; JAK, Janus associated kinase; STAT, signal transducer and activator of transcription.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss fedratinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/212327Orig1s000MultidisciplineR.pdf (FDA website with product labels and initial multidiscipline review of the safety and efficacy of fedratinib; states that patients with myelofibrosis frequently have elevations in bilirubin and serum enzymes, but patients treated with fedratinib have a higher rate of ALT elevations [58%] compared to placebo [17%], but these elevations are generally mild and above 5 times ULN in 9% vs 1% with placebo; despite this, significant liver injury attributable to fedratinib is uncommon).
Zhang M, Xu CR, Shamiyeh E, Liu F, Yin JY, von Moltke LL, Smith WB. (2014). A randomized, placebo-controlled study of the pharmacokinetics, pharmacodynamics, and tolerability of the oral JAK2 inhibitor fedratinib (SAR302503) in healthy volunteers. J Clin Pharmacol. (A pharmacologic study in 57 healthy controls given one of 7 doses of fedratinib, found significant inhibition of STAT-signaling with doses of 300 mg or higher).
Pardanani A, Harrison C, Cortes JE, Cervantes F, Mesa RA, Milligan D, Masszi T, et al. (2015). Safety and efficacy of fedratinib in patients with primary or secondary myelofibrosis: a randomized clinical trial. JAMA Oncol. (Among 289 adults with myelofibrosis treated with fedratinib [400 or 500 mg] or placebo daily for 24 weeks, spleen responses occurred in 36% and 40% on fedratinib vs 1% on placebo and symptom responses in 36% and 34% vs 7%, while adverse events occurred in almost all patients, including ALT elevations in 46% and 53% vs 17%, but values above 5 times ULN arose in only 3% and 3% vs none; severe adverse events included 4 cases of suspected Wernicke’s encephalopathy in fedratinib treated subjects).
Pardanani A, Tefferi A, Jamieson C, Gabrail NY, Lebedinsky C, Gao G, Liu F, et al. (2015). A phase 2 randomized dose-ranging study of the JAK2-selective inhibitor fedratinib (SAR302503) in patients with myelofibrosis. Blood Cancer J. (Among 31 patients with myelofibrosis treated with fedratinib [400, 500 or 600 mg once daily] for 24 weeks, reduction in spleen size averaged 30%, 33% and 43%, and all patients had at least one adverse event, ALT elevations being frequent [30%, 50%, and 91% ), two patients developing ALT levels above 5 times and one above 20 times ULN accompanied by jaundice, symptoms and signs of hepatic failure which resolved after fedratinib was discontinued).
Harrison CN, Schaap N, Vannucchi AM, Kiladjian JJ, Tiu RV, Zachee P, Jourdan E, et al. (2017). Janus kinase-2 inhibitor fedratinib in patients with myelofibrosis previously treated with ruxolitinib (JAKARTA-2): a single-arm, open-label, non-randomised, phase 2, multicentre study. Lancet Haematol. (Among 83 patients with myelofibrosis resistant or intolerant to ruxolitinib who were treated with fedratinib for 24 weeks, 55% had a clinical response [at least a 35% reduction in spleen size] while side effects included diarrhea [58%], nausea [56%] constipation [21%], pruritus [16%], fatigue [15%], headache [13%], ALT elevations [6%], cardiac failure [3%], and tumor lysis syndrome [2%]).
(2019). Fedratinib becomes new option in myelofibrosis. Cancer Discov. (News report on the approval of fedratinib for therapy of myelofibrosis after a hold had been placed on it for several years because of cases of Wernicke’s encephalopathy, although only one was proven).
Blair HA. (2019). Fedratinib: first approval. Drugs. (Review of the history of development, mechanism of action, pharmacology, clinically efficacy and safety of fedratinib shortly after its approval in the US for immediate- and high-risk myelofibrosis mentions that common adverse reactions are diarrhea, nausea and anemia, less common but potentially serious reactions include Wernicke’s encephalopathy, myelosuppression, gastrointestinal toxicity, amylase and lipase elevations and serum aminotransferase elevations, which occur in 43% of treated subjects versus 14% in placebo controls, but are above 5 times ULN in only 9% vs 1%).
Talpaz M, Kiladjian JJ. (2021). Fedratinib, a newly approved treatment for patients with myeloproliferative neoplasm-associated myelofibrosis. Leukemia. (Review of the clinical features and pathogenesis of myelofibrosis and the mechanism of action, pharmacology, clinical efficacy and safety of fedratinib).
Coltro G, Vannucchi AM. (2021). The safety of JAK kinase inhibitors for the treatment of myelofibrosis. Expert Opin Drug Saf. (Review of the mechanism of action and safety of JAK inhibitors used in the treatment of myelofibrosis including fedratinib and ruxolitinib as well as several experimental agents; mentions that fedratinib has been associated with ALT elevations during therapy).
Pardanani A, Tefferi A, Masszi T, Mishchenko E, Drummond M, Jourdan E, Vannucchi A, et al. (2021). Updated results of the placebo-controlled, phase III JAKARTA trial of fedratinib in patients with intermediate-2 or high-risk myelofibrosis. Br J Haematol. (Updated analysis of the randomized controlled trial of fedratinib in patients with myelofibrosis that had been placed on hold in 2013 because of serious adverse events [Wernicke’s encephalopathy], based up 96 enrolled subjects treated with 400 mg of fedratinib vs 96 treated with placebo for 24 weeks, in whom spleen responses occurred in 47% vs 1% and improved symptom burden in 40% vs 9%, common adverse events being diarrhea [66%], nausea [62%], anemia [40%], vomiting [39%], fatigue [19%], muscle spasms [12%], creatinine elevations [59% vs 19%], lipase elevations [35% vs 7%] and ALT elevations [43% vs 14%] being 5 times ULN or more [1% vs none] with no patient developing clinically apparent liver injury).
Harrison CN, Schaap N, Vannucchi AM, Kiladjian JJ, Passamonti F, Zweegman S, Talpaz M, et al. (2022). Safety and efficacy of fedratinib, a selective oral inhibitor of Janus kinase-2 (JAK2), in patients with myelofibrosis and low pretreatment platelet counts. Br J Haematol. (Reanalysis of trials of fedratinib in patients with myelofibrosis comparing those with low vs higher platelet counts [50,000 to 100,000 vs >100,000 per µL] found that response rates were similar and adverse event rates were similar except for thrombocytopenia; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Fedratinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Fedratinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Fedratinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fedratinib)